# Famotidine

## OVERVIEW

### Introduction

Famotidine is a histamine type 2 receptor antagonist (H2 blocker) which is commonly used for treatment of acid-peptic disease and heartburn. Famotidine has been linked to rare instances of clinically apparent acute liver injury.

### Background

Famotidine (fam oh' ti deen) was the third H2 blocker introduced into clinical practice in the United States and is a commonly used agent for treatment of duodenal and gastric ulcer and gastroesophageal reflux disease. The H2 blockers are specific antagonists of the histamine type 2 receptor, which is found on the basolateral (antiluminal) membrane of gastric parietal cells. The binding of famotidine to the H2 receptor results in inhibition of acid production and secretion, and improvement in symptoms and signs of acid-peptic disease. The H2 blockers inhibit an early, “upstream” step in gastric acid production and are less potent that the proton pump inhibitors, which inhibit the final common step in acid secretion. Nevertheless, the H2 blockers inhibit 24 hour gastric acid production by about 70% and are most effective in blocking basal and nocturnal acid production. Famotidine was first approved for use in the United States in 1986 and more than 3 million prescriptions for it are filled yearly. Famotidine is now available both by prescription and over-the-counter. The listed indications for famotidine are duodenal and gastric ulcer disease, gastroesophageal reflux and prevention of stress ulcers. Famotidine is available in tablets of 20 and 40 mg in several generic forms and in parenteral forms under the brand name Pepcid. Over-the-counter formulations are typically gelcaps or tablets of 10 or 20 mg. Liquid solutions are also available for intravenous use. The typical recommended dose for therapy of peptic ulcer disease in adults is 40 mg once daily for 4 to 8 weeks and maintenance therapy of 20 mg daily. Lower, chronic and intermittent doses of famotidine are used for therapy of heartburn and indigestion. Side effects are uncommon, usually minor, and include diarrhea, constipation, fatigue, drowsiness, headache and muscle aches. Famotidine is metabolized by the hepatic cytochrome P450 system, but has minimal inhibitory effects on the metabolism of other drugs, making it less likely to cause drug-drug interactions than cimetidine.

### Hepatotoxicity

Chronic therapy with famotidine has been associated with minor elevations in serum aminotransferase levels in 1% to 4% of patients, but similar rates were reported in placebo recipients. The ALT elevations are usually asymptomatic and transient, and may resolve without dose modification. Rare instances of clinically apparent liver injury have been reported in patients receiving famotidine, but few cases have been reported and clinical characteristics in published cases have varied in the time to onset and pattern of injury. Onset has ranged from 1 to 14 weeks and serum enzyme pattern has typically been hepatocellular. The injury resolves within 4 to 12 weeks of stopping famotidine. Immunoallergic features (rash, fever, eosinophilia) are uncommon, as is autoantibody formation.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

Famotidine is metabolized by the microsomal P450 drug metabolizing enzymes and injury may be the result of its activation to a toxic intermediate.

### Outcome and Management

The hepatic injury caused by famotidine is usually rapidly reversible with stopping the medication (Case 1). Famotidine has not been definitively linked to cases of acute liver failure, chronic hepatitis, prolonged cholestasis or vanishing bile duct syndrome. The results of rechallenge have not been reported. There appears to be cross reactivity in hepatic injury with cimetidine (Case 2). If acid suppression is required, use of an unrelated proton pump inhibitor is probably prudent for patients with clinically apparent famotidine induced liver injury.

The H2 receptor blockers include cimetidine, famotidine, nizatidine, and ranitidine. Combined general references on the H2 receptor blockers are given together after this overview section, while specific references are provided in the separate section on each drug. See also the Proton Pump Inhibitors.

Drug Class: Antiulcer Agents

Other Drugs in the Subclass, Histamine Type 2 Receptor Antagonists: Cimetidine, Nizatidine, Ranitidine

## CASE REPORTS

### Case 1. Mild acute liver injury due to famotidine.

[Modified from: Ament PW, Roth JD, Fox CJ. Famotidine-induced mixed hepatocellular jaundice. Ann Pharmacother 1994; 28: 40-2. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/8123957)]

A 55 year old man with gastritis and abdominal pain was treated with ranitidine (150 mg twice daily) for 5 days and, when symptoms continued, was switched to famotidine (20 mg twice daily) and sucralfate (1 g four times daily). One week later he developed nausea and jaundice. He denied fever, chills, rash or pruritus. He had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. He had been taking acetaminophen for the previous ten days (625 mg four times daily). On physical examination, he was jaundiced and had tenderness over the liver, but no fever, rash or signs of chronic liver disease. Laboratory results showed elevations in serum bilirubin with moderate elevations in serum ALT and alkaline phosphatase (Table). He tested negative for markers of viral hepatitis (A, B and C) and for autoimmune liver disease. Acetaminophen levels were normal (7 µg/mL: normal therapeutic range 10-20). Abdominal ultrasound showed no gallstones or evidence of biliary obstruction. Famotidine was stopped and he rapidly improved. A liver biopsy was not done. When seen five weeks later, all laboratory tests had returned to normal.

#### Key Points

Medication: | Famotidine (40 mg daily)
Pattern: | Hepatocellular (R=6.1)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 1 week
Recovery: | 5 weeks
Other medications: | Acetaminophen (~2.5 g daily)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 34 | 67 | 0.9
7 days | 0 | 305 | 182 | 7.1 | Admission
8 days | 1 day | 250 | 162 | 6.7
10 days | 3 days | 168 | 130 | 2.7
16 days | 9 days | 69 | 88 | 1.3
5 weeks | 4 weeks | 26 | 61 | 1.1
Normal Values | | <25 | <90 | <1.2

* Bilirubin levels converted using formula of 17.1 µmol/L = 1.0 mg/dL.

#### Comment

This patient developed a mild acute hepatitis 1 week after starting famotidine. While he had also been taking moderate doses of acetaminophen (2.5 g per day for 10 days), the pattern of injury was not typical of acetaminophen hepatotoxicity and acetaminophen levels were actually below the therapeutic range and well below the toxic range on admission. The pattern and course of the liver injury was quite typical of idiosyncratic drug induced liver injury and compatible with the type of injury that has been reported with H2 blockers with a short latency (1 week), a hepatocellular or mixed pattern of liver enzyme elevation and rapid recovery upon stopping. An issue is whether the 5 days of ranitidine may have caused or contributed to the injury and whether there may be cross sensitivity to hepatic injury among the various H2 blockers. Such cross sensitivity has been shown between famotidine and cimetidine (Case 2 below).

### Case 2. Acute liver injury due to famotidine and recurrence due to cimetidine.

[Modified from: Hashimoto F, Davis RL, Egli D. Hepatitis following treatments with famotidine and then cimetidine. Ann Pharmacother 1994; 28: 37-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/8123956)]

A 51 year old woman with symptomatic duodenal ulcer disease was treated with famotidine (40 mg daily), with subsequent improvement in epigastric pain and nausea, but with reappearance of abdominal discomfort followed by dark urine, itching and jaundice starting 3 weeks later. She denied fever or rash or history of drug allergy. She was overweight (BMI = 34.1), but had lost 2.3 kilograms in the previous week. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. On examination, she was jaundiced and had mild hepatic tenderness but no peripheral signs of chronic liver disease. Laboratory testing showed total serum bilirubin of 5.0 (direct 4.1) mg/dL, ALT 661 U/L, alkaline phosphatase 193 U/L, with normal serum albumin and prothrombin time (Table). Tests for hepatitis A, B and C were negative as were autoantibodies. Ultrasound of the abdomen showed an echogenic liver suggestive of steatosis, but no evidence of biliary obstruction. Famotidine was stopped and omeprazole (20 mg daily) substituted. She improved rapidly and liver tests were normal or near normal five weeks later, at which point cimetidine (800 mg daily) was substituted for omeprazole. One week later she redeveloped abdominal pain and nausea. The dose of cimetidine was increased, but over the next week she developed worsening symptoms and dark urine. Laboratory testing showed rises in serum bilirubin, ALT and alkaline phosphatase similar to those after famotidine therapy and cimetidine was stopped. Repeat evaluation revealed no evidence of viral hepatitis, autoimmune liver disease or biliary obstruction. She improved and was maintained on omeprazole therapy for her acid-peptic disease. In follow up 6 weeks later, liver tests had returned to normal or near-normal levels.

#### Key Points

Medication: | Famotidine (40 mg daily), cimetidine (800 to 1200 mg daily)
Pattern: | Hepatocellular (R=14)
Severity: | 3 (jaundice, hospitalization)
Latency: | 3-4 weeks for famotidine, 1-2 weeks for cimetidine
Recovery: | 6 weeks
Other medications: | Antacids, occasional acetaminophen, oral contraceptives (many years)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Famotidine (40 mg/day) started
4 weeks | 0 | 661 | 193 | 5.0 | Famotidine stopped
5 weeks | 1 | 250 | 250 | 1.5 | Symptoms resolved
6 weeks | 2 | 120 | 150 | 1.0
9 weeks | 5 | 55 | | | Cimetidine started
11 [2] weeks | [0] | 590 | 180 | 4.4 | Cimetidine stopped
[3] weeks | [1] week | 430 | 320 | 8.2
[4] weeks | [2] weeks | 190 | 210 | 1.2
[5] weeks | [3] weeks | 90 | 180
[7] weeks | [5] weeks | 48 | 120 | 1.0
[9] weeks | [7] weeks | 44 | 60
Normal Values* | | <35 | <150 | <1.2

* Some values estimated from Figure 1, and bilirubin levels converted from µmol to mg/dL. Weeks in parentheses represent time after starting and stopping cimetidine.

#### Comment

This patient appeared to develop a transient and self-limiting acute hepatitis-like injury after both famotidine and cimetidine therapy. The cross reactivity of these two agents was not suspected, based upon the lack of such cross reactivity to hepatic injury between cimetidine and ranitidine. However, in the case shown above, the recurrence was more rapid and perhaps slightly more severe with the “re-exposure” using cimetidine. Typical of H2 receptor blocker induced liver injury was the rapid recovery upon withdrawal. While liver biopsy was not done, in most such instances centrolobular necrosis with inflammation and mild cholestasis is found. This patient may have had mild underlying nonalcoholic fatty liver disease, but this is a common medical condition and unlikely played a role in the clinically apparent liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Famotidine – Generic, Pepcid®

DRUG CLASS

Antiulcer Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Famotidine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Famotidine | 76824-35-6 | C8-H15-N7-O2-S3 | Famotidine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 January 2018

Zimmerman HJ. H2 Receptors antagonists. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 719-20. (Expert review of hepatotoxicity published in 1999 states that cimetidine and ranitidine, despite enormous use, have been implicated in a small number of cases of hepatic injury, 39 for cimetidine, 35 for ranitidine and 1 for famotidine, all cases recovering and signs of hypersensitivity being rare).
Wallace JL, Sharkey KA. Pharmacotherapy of gastric acidity, peptic ulcers, and gastroesophageal reflux disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1309-22. (Textbook of pharmacology and therapeutics).
Black M. Hepatotoxic and hepatoprotective potential of histamine (H2)-receptor antagonists. Am J Med 1987; 83: 68-75. (Review of hepatotoxicity of cimetidine and ranitidine and their potential role in ameliorating acetaminophen hepatotoxicity, perhaps via their inhibition of P450 activity). 2892410
Dobrilla G, De Pretis G, Piazzi L, Boero A, Camarri E, Crespi M, Fontana G, et al. Comparison of once-daily bedtime administration of famotidine and ranitidine in the short-term treatment of duodenal ulcer. A multicenter, double-blind, controlled study. Scand J Gastroenterol Suppl 1987; 134: 21-8. (Controlled trial comparing famotidine and ranitidine in 234 patients with duodenal ulcer disease; all had normal ALT levels at the end of therapy except for one [chronic alcoholic] patient who developed elevated aminotransferase levels on famotidine; no details given). 2889255
Lewis JH. Hepatic effects of drugs used in the treatment of peptic ulcer disease. Am J Gastroenterol 1987; 82: 987-1003. (Thorough review of hepatotoxicity of antiulcer medications; 10 published cases of hepatotoxicity due to cimetidine and 12 for ranitidine, none fatal and not all convincingly due to the medication; little information available on famotidine or nizatidine). 2889354
Saigenji K, Fukutomi H, Nakazawa S. Famotidine: postmarketing clinical experience. Scand J Gastroenterol Suppl 1987; 134: 34-40. (Postmarketing survey of 6436 Japanese patients on famotidine found side effects in <1% and liver test elevations in 33 [<0.5%], resolving in 11 of 25 who continued therapy). 2889256
Ament PW, Roth JD, Fox CJ. Famotidine-induced mixed hepatocellular jaundice. Ann Pharmacother 1994; 28: 40-2. (55 year old developed jaundice following treatment with 1 week of ranitidine and 1 week of famotidine [bilirubin 7.1 mg/dL, ALT 305 U/L, Alk P 182 U/L] with rapid resolution on stopping: Case 1). 8123957
Hashimoto F, Davis RL, Egli D. Hepatitis following treatments with famotidine and then cimetidine. Ann Pharmacother 1994; 28: 37-9. (51 year old developed pain and jaundice 3-4 weeks after starting famotidine [bilirubin 5 mg/dL, ALT 661 U/L, Alk P 193 U/L], recovering rapidly on omeprazole but with recurrence 1 week after starting cimetidine [bilirubin 8 mg/dL, ALT ~590 U/L, Alk P ~320 U/L], with rapid improvement on switching again to omeprazole: Case 2). 8123956
Howden CW, Tytgat GN. The tolerability and safety profile of famotidine. Clin Ther 1996; 18: 36-54. (Analysis of safety in 7483 patients in 27 trials of famotidine; side effects were uncommon [<1% for any specific symptom] and no more common than with placebo or comparator agents such as ranitidine; ALT elevations occurred in 2.2% on famotidine, 2.0% on ranitidine and 2.7% on placebo; only 1 patient discontinued famotidine because of elevation of liver tests). 8851452
García Rodríguez LA, Ruigómez A, Jick H. A review of epidemiologic research on drug-induced acute liver injury using the general practice research data base in the United Kingdom. Pharmacotherapy 1997; 17: 721-8. (Combined analysis of 8 epidemiologic studies using the UK General Practice Research Database estimated incidence rates of acute liver injury to be highest for isoniazid and chlorpromazine [4 and 1.3 per 1000 users], intermediate for amoxicillin-clavulanate, cimetidine and ranitidine [2.3, 2.3 and 0.9 per 10,000], and lowest for trimethoprim/ sulfamethoxazole, omeprazole, amoxicillin and nonsteroidals [5.2, 4.3, 3.9 and 3.7 per 100,000]; famotidine not discussed). 9250549
García Rodríguez LA, Wallander MA, Stricker BH. The risk of acute liver injury associated with cimetidine and other acid-suppressing anti-ulcer drugs. Br J Clin Pharmacol 1997; 43: 183-8. (Case control study in cohort of 100,000 users of antiulcer drugs in a UK general practice database; 33 cases of acute liver injury found, 12 on cimetidine for a relative risk [RR] of 5.5, 1 on omeprazole and 5 on ranitidine did not raise RR above baseline. Latency was <2 months in 80% of cases; most antiulcer drug cases had hepatocellular or mixed enzyme patterns [15 of 18]). 9131951
Sohn JH, Sohn YW, Jeon YC, Han DS, Hahm JS, Choi HS, Park KN, Kee CS. Three cases of hepatitis related to the use of famotidine and ranitidine. Korean J Hepatol 1998; 4: 194-9. Not in PubMed (Two cases of hepatotoxicity attributed to famotidine: 54 year old woman developed jaundice 6 weeks after starting famotidine [bilirubin 12 mg/dL, ALT 1520 U/L, Alk P 153], resolving within 2 months of stopping; a 45 year old man developed jaundice 6 weeks after restarting famotidine [bilirubin 14 mg/dL, ALT 58 U/L, Alk P 207 U/L], resolving within 3 months of stopping).
Jiménez-Sáenz M, Argüelles-Arias F, Herrerías-Gutiérrez JM, Durán-Quintana JA. Acute cholestatic hepatitis in a child treated with famotidine. Am J Gastroenterol 2000; 95: 3665-6. (13 year old developed jaundice 75 days after stopping a 30-day course of famotidine, with bilirubin rising from 9 to 26 mg/dL, ALT 1080 to 2400 U/L, Alk P 634 U/L, recovering in 2-3 months). 11151926
Fisher AA, Le Couteur DG. Nephrotoxicity and hepatotoxicity of histamine H2 receptor antagonists. Drug Saf 2001; 24: 39-57. (Review of renal and hepatic complications of H2 blocker therapy). 11219486
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug-induced acute liver failure, but none were attributed to an H2 blocker or proton pump inhibitor). 15390328
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug-induced liver injury [2.4/100,000 person years]; 3 cases were attributed to cimetidine for an odds ratio of 2.0 compared to controls [n=5000] which was not statistically significant; famotidine not discussed). 15206996
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002: 103 cases identified as highly probable, probable or possible, one case attributed to ranitidine and one to omeprazole, none attributed to famotidine). 16165719
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Population based survey of 126 cases of acute liver injury due to drugs between 1993-1999 in Spain; 8 were attributed to ranitidine alone [incidence 5.1/100,000 person-years] and 5 to omeprazole alone [2.1/100,000]; famotidine not mentioned). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 2 were attributed to ranitidine, none to famotidine or other antiulcer medications). 18955056
Gupta N, Patel C, Panda M. Hepatitis following famotidine: a case report. Cases J 2009; 2: 89. (47 year old man with chronic hepatitis C developed an acute rise in ALT within 3 days of laparoscopic cholecystectomy and 36 hours after starting famotidine [ALT 4755 U/L, AST 8466 U/L, bilirubin 2.5 mg/dL, INR 2.4], with rapid recovery within 10 days of stopping). 19173722
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children; no antiulcer medication was among the top 40 causes). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were caused by antiulcer medications). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to famotidine or other antiulcer medications). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most commonly implicated agents being nimesulide [n=53], cyproterone [n=18], nitrofurantoin [n=17] and antituberculosis drugs [n=13]; no case was linked to famotidine or other antiulcer agent). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 cases were attributed to antiulcer medications, 3 to ranitidine and 3 to PPIs, but none to famotidine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Famotidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Famotidine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Famotidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Famotidine)